# Pegcetacoplan

## OVERVIEW

### Introduction

Pegcetacoplan is a small peptide inhibitor of complement that is used to treat adults with paroxysmal nocturnal hemoglobinuria. Serum aminotransferase elevations occur in a proportion of patients treated pegcetacoplan, but episodes of clinically apparent liver injury with jaundice have not been reported with its use.

### Background

Pegcetacoplan (peg set’ a koe’ plan) is a subcutaneously administered small peptide inhibitor of complement C3 and its activation fragment C3b that blocks the cleavage of C3 and the downsteam effectors of completement activation. Pegcetacoplan is used in conditions marked by excessive activation of complement including paroxysmal nocturnal hemoglobinuria (PNH), age-related macular degeneration, and some forms of glomerulonephritis. PNH is a rare, acquired disease caused by lack of the regulatory proteins CD55 and CD59 on the surface of red blood cells. Without these factors, the red cells are susceptible to complement activation, which causes episodes of hemolysis and thromboses. Previous therapies for PNH included two monoclonal inhibitors of complement C5 (eculizumab and ranukinumab) which were effective in decreasing intravascular hemolysis but not extravascular hemolysis, which is the result of complement activation upstream of C5. In a prospective controlled trial in patients with only partial response to eculizumab, the switch to pegcetacoplan resulted in better control of the hemolytic anemia, higher hemoglobin levels, and improvement in symptoms and quality of life. Pegcetacoplan was also found to be superior to eculizumab as first line therapy of PNH naïve to complement inhibitors. Pegcetacoplan was approved in the United States in 2021 for adults with PNH, either as initial therapy or after switching from intravenous eculizumab or ranukinumab. Pegcetacoplan is available in solution in single use vials of 1080 mg in 20 mL (54 mg/mL). The recommended dosage is 1080 mg administered by subcutaneous infusion twice weekly. The most common adverse events include injection site reactions, infections, diarrhea, abdominal pain, respiratory tract infections, pain, fatigue, cough, arthralgia, dizziness, headache, and rash, many of which are more likely due to the underlying condition than the therapy. Laboratory abnormalities include hypokalemia. Potential severe adverse events include hypersensitivity reactions and serious infections caused by encapsulated bacteria including Streptococcus pneumoniae, Neisseria meningitidis and Haemophilus influenzae type B, for which reason pegcetacoplan has a boxed warning and recommendations for vaccination before starting therapy. An increase in risk of these infections has yet to be shown with use of pegcetacoplan in adult patients with PNH.

### Hepatotoxicity

In the prelicensure clinical trials of pegcetacoplan in patients with PNH, ALT elevations were rarely described, and there were no reports of hepatic adverse events or discontinuations because of abnormal liver tests. Serum ALT and AST elevations are not uncommon in patients with untreated PNH, usually due to hemolysis, thromboses, or infections. In the open label and controlled trials supporting the approval of pegcetacoplan, there were instances of cholecystitis and portal vein thromboses, but no mention of drug induced liver injury. Since its approval in the United States and Europe, there have been no reported cases of clinically apparent liver injury associated with pegcetacoplan therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from pegcetacoplan is unknown but suspected to be due to the underlying hemolysis or thromboses and unrelated to therapy. Pegcetacoplan is comprised of two identical 15-aminoacid peptides covalently joined by a molecule of polyethylene glycol (PEG). It is metabolized by cellular peptidases into small peptide fragments which are unlikely to be harmful, immunogenic, or toxic. Pegcetacoplan is not metabolized by the cytochrome P450 system and has no effect of CYP metabolizing enzymes.

### Outcome and Management

The product label for pegcetacoplan does not recommend routine monitoring of liver laboratory tests during therapy. Serum aminotransferase elevations above 5 times the upper limit of normal (if detected) should lead to dose reduction or temporary cessation of treatment with careful monitoring if restarted after resolution of the abnormalities. Elevations of aminotransferase levels accompanied by jaundice or symptoms of liver injury should trigger discontinuation of therapy. Cross sensitivity to liver injury has not been described with the other complement inhibitors used to treat PNH, eculizumab and ravulizumab.

Drug Class: Hematologic Agents

Other Complement Inhibitors: Eculizumab, Ravulizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pegcetacoplan – Empaveli®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pegcetacoplan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pegcetacoplan | 2019171-69-6 (https://pubchem.ncbi.nlm.nih.gov/substance/381128213) | Peptide | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2024

Abbreviations: PNH, paroxysmal nocturnal hemoglobinuria; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of complement inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215014Orig1s000IntegratedR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of pegcetacoplan as therapy of PNH, describes the adverse events observed in a pooled safety population which were largely due to episodes of hemolysis, thromboses, and infections, and while elevations in liver enzymes were not infrequent in some studies, they were attributed to hemolysis, thromboses and infections rather than liver injury due to pegcetacoplan).
Hillmen P, Szer J, Weitz I, Röth A, Höchsmann B, Panse J, Usuki K, et al. Pegcetacoplan versus eculizumab in paroxysmal nocturnal hemoglobinuria. N Engl J Med. 2021;384:1028-1037. (Among 80 adults with PNH and incomplete response to eculizumab [hemoglobin less than 10.5 g/dL] treated with pegcetacoplan vs eculizumab, mean hemoglobin levels improved only with pegcetacoplan [rising to 11.5 vs 8.6 g/dL], fewer required transfusions [15% vs 85%], and fatigue and quality of life improved, while adverse event rates included infusion site reactions [37% vs 3%], diarrhea [22% vs 3%], breakthrough hemolysis [10% vs 23%], headache [7% vs 23%], fatigue [5% vs 15%]; no mention of ALT elevations or hepatic adverse events). 33730455
Hoy SM. Pegcetacoplan: first approval. Drugs. 2021;81:1423-1430. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of pegcetacoplan in PNH, age-related macular degeneration, C3 glomerulopathy, and autoimmune hemolytic anemia; no mention of ALT elevations or hepatic adverse events). 34342834
Wong RSM, Pullon HWH, Amine I, Bogdanovic A, Deschatelets P, Francois CG, Ignatova K, et al. Inhibition of C3 with pegcetacoplan results in normalization of hemolysis markers in paroxysmal nocturnal hemoglobinuria. Ann Hematol. 2022;101:1971-1986. (Among 23 previously untreated adults with PNH who were treated with pegcetacoplan for 1 year, mean hemoglobin levels rapidly rose into the normal range and therapy was generally well tolerated; there were no hepatic severe adverse events and no mention of serum ALT elevations). 35869170
de Latour RP, Szer J, Weitz IC, Röth A, Höchsmann B, Panse J, Usuki K, et al. Pegcetacoplan versus eculizumab in patients with paroxysmal nocturnal haemoglobinuria (PEGASUS): 48-week follow-up of a randomised, open-label, phase 3, active-comparator, controlled trial. Lancet Haematol. 2022;9:e648-e659. (Among 80 adults with PNH and an incomplete response to eculizumab treated with pegcetacoplan or continued on eculizumab for 16 weeks [Hillmen 2021], 77 who were continued on open label pegcetacoplan for 32 weeks maintained a clinical response, while common treatment emergent adverse events included infusion site reactions [26%], hemolysis [19%], diarrhea [12%], fatigue [10%], headache [10%], and cough [10%], and there were no liver related serious adverse events and no mention of ALT elevations). 36055332
Heo YA. Pegcetacoplan: A review in paroxysmal nocturnal haemoglobinuria. Drugs. 2022;82:1727-1735. (Review of the mechanism of action, clinical efficacy, and safety of pegcetacoplan for PNH, describes its effects mediated by inhibition of C3, an upstream step in the complement cascade which may explain its superior efficacy compared to inhibitors of C5 [eculizumab and ravulizumab]; in short discussion of safety, no mention of ALT elevations or hepatic adverse events). 36459381
Wong RSM, Navarro-Cabrera JR, Comia NS, Goh YT, Idrobo H, Kongkabpan D, Gómez-Almaguer D, et al. Pegcetacoplan controls hemolysis in complement inhibitor-naive patients with paroxysmal nocturnal hemoglobinuria. Blood Adv. 2023;7:2468-2478. (Among 26 adults with previously untreated PNH enrolled in two open label trials of pegcetacoplan, there was a rapid improvement in hemoglobin levels in all, but treatment emergent adverse events were frequent, and 3 participants discontinued therapy because of adverse events [hypersensitivity reaction, ovarian cancer, and aplastic anemia], but none were attribute to liver injury; no mention of ALT levels). 36848639
Pegcetacoplan (Syfovre) for geographic atrophy in age-related macular degeneration. Med Lett Drugs Ther. 2023;65:49-50. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of pegcetacoplan shortly after its approval as therapy of geographic atrophy in age-related macular degeneration given as intravitreal injections every one to two months, no mention of hepatic adverse events). 37020339
Heier JS, Lad EM, Holz FG, Rosenfeld PJ, Guymer RH, Boyer D, Grossi F, et al.; OAKS and DERBY study investigators. Pegcetacoplan for the treatment of geographic atrophy secondary to age-related macular degeneration (OAKS and DERBY): two multicentre, randomised, double-masked, sham-controlled, phase 3 trials. Lancet. 2023;402(10411):1434-1448. (Among 1258 patients with age-related macular degeneration and geographic atrophy enrolled in two 24 month randomized, sham controlled trials of intravitreal injections of pegcetacoplan, there was a 16% to 22% slowing of growth of geographic atrophy lesions but no differences in visual function or acuity; no mention of ALT levels or hepatic adverse events). 37865470
Patriquin CJ, Bogdanovic A, Griffin M, Kelly RJ, Maciejewski JP, Mulherin B, Peffault de Latour R, et al. Safety and efficacy of pegcetacoplan in adult patients with paroxysmal nocturnal hemoglobinuria over 48 weeks: 307 Open-Label Extension Study. Adv Ther. 2024;41:2050-2069. (Among 137 patients with PNH enrolled in a long term, open label, extension trial of pegcetacoplan, efficacy was maintained with hemoglobin levels rising from a mean of 8.9 to 11.6 g/dL, no transfusions were required in 83% of subjects, and no thrombotic events or meningococcal infections occurred; most severe adverse events were due to hemolysis breakthrough; no mention of ALT elevations or hepatic adverse events). 38573482

## OTHER REFERENCE LINKS

Recent References on Pegcetacoplan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pegcetacoplan/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Pegcetacoplan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pegcetacoplan)